# Miltefosine

## OVERVIEW

### Introduction

Miltefosine is an orally available, alkyl phospholipid that is used in the treatment of both cutaneous and visceral leishmaniasis. Miltefosine therapy is often accompanied by transient mild-to-moderate serum aminotransferase elevations during the first 1 or 2 weeks of treatment, but has not been implicated in cases of clinically apparent liver injury with jaundice.

### Background

Miltefosine (mil" te foe' sin) is an alkylated phosphocholine that has in vitro and in vivo activity against several bacteria, fungi and parasites including several Leishmania species. Miltefosine appears to act by affecting phospholipid membrane integrity and mitochondria function of the microorganism. Miltefosine has been shown to be effective in inducing cures of visceral (kala azar), mucosal and cutaneous leishmaniasis in a high proportion of patients. Miltefosine was approved for use in India in 2002 and in the United States in 2014 and was the first oral therapy of visceral and cutaneous leishmaniasis. It is available as capsules of 50 mg under the commercial name Impavido. The recommended dose is 50 mg twice (body weight 30 to 44 kg) or three times (45 kg or above) daily for 28 days. Miltefosine also has been reported to be effective in other serious bacterial, fungal and parasitic conditions such as amebiasis (primary amoebic meningoencephalitis), trypanosoma cruzii infection (Chagas disease), cryptococcosis and candidiasis, but is not formally approved for these conditions. Miltefosine is generally well tolerated, but side effects can include nausea, vomiting, diarrhea, abdominal discomfort, anorexia, pruritus, headache, dizziness and somnolence. Rare, but potentially severe adverse events include decrease in reproductive capacity, embryo-fetal toxicity, renal dysfunction and hypersensitivity reactions including Stevens Johnson syndrome. While miltefosine is rarely used in the United States, it is an important medication from a worldwide perspective and has played an essential role in public health efforts to eradicate visceral and cutaneous leishmaniasis.

### Hepatotoxicity

Serum aminotransferase levels are frequently elevated in patients with visceral leishmaniasis and miltefosine therapy regularly results in a decline in mean values into the normal range. In prospective studies of miltefosine therapy, however, as many as half of patients had mild-to-moderate ALT elevations during therapy, although values above 5 times ULN were rare (<1%). The serum aminotransferase elevations were transient, generally arising during the first few weeks of therapy and ultimately resolving without dose adjustments or drug interruptions. There have been no case reports of clinically apparent liver injury with jaundice attributed to miltefosine therapy. Thus, significant liver injury from miltefosine must be very rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible causes of liver injury from miltefosine therapy are not known. Miltefosine is a simple, modified phosphocholine and is metabolized in many cells. The relative toxicity of miltefosine for parasites and other microorganisms as opposed to human cells probably relates to differences in phosphocholine metabolism. It does, however, have embryo-fetal toxicity in humans. Miltefosine has no known drug-drug interactions.

### Outcome and Management

The serum aminotransferase and alkaline phosphatase elevations that occur during miltefosine therapy are typically asymptomatic and self-limited and do not require dose adjustment or discontinuation. Appearance of frank jaundice or symptoms accompanying liver test abnormalities during therapy of leishmaniasis with miltefosine should lead to temporary discontinuation and careful search for other possible causes of liver injury.

Drug Class: Antiinfective Agents, Leishmaniasis Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Miltefosine – Impavido®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Miltefosine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Miltefosine | 58066-85-6 | C21-H46-N-O4-P | Miltefosine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2017

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. pp 589-637. (Expert review of hepatotoxicity published in 1999; miltefosine is not discussed).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibiotics; miltefosine is not discussed).
Sundar S, Rosenkaimer F, Makharia MK, Goyal AK, Mandal AK, Voss A, Hilgard P, Murray HW. Trial of oral miltefosine for visceral leishmaniasis. Lancet 1998; 352(9143): 1821-3. (Among 30 Indian men with visceral leishmaniasis treated with one of six dose regimens of oral miltefosine [50 mg every other day to 250 mg daily] for 28 days, all responded to therapy and 21 were cured; side effects included vomiting, diarrhea and renal insufficiency and were severe in the highest dose groups; no mention of ALT elevations or hepatotoxicity). 9851383
Sundar S, Jha TK, Thakur CP, Engel J, Sindermann H, Fischer C, Junge K, et al. Oral miltefosine for Indian visceral leishmaniasis. N Engl J Med 2002; 347: 1739-46. (Among 299 Indian patients [age above 12 years] with visceral leishmaniasis treated with miltefosine [50 or 100 mg by mouth daily for 28 days] or amphotericin B [1 mg/kg intravenously every other day for 30 days], long term cure rates were 94% vs 96% and side effects of miltefosine included vomiting [38%], diarrhea [20%], and ALT elevations [51%] that were above 5 times ULN in only 1 patient [<1%]; no discontinuations for liver test abnormalities, but one patient developed Stevens Johnson syndrome). 12456849
Singh UK, Prasad R, Kumar R, Jaiswal BP. Miltefosine in children with visceral leishmaniasis. Indian Pediatr 2006; 43: 1076-80. (Among 64 Indian children with visceral leishmaniasis treated with miltefosine for 28 days, the 6 month cure rate was 97% and side effects included ALT elevations above 3 times ULN in 61%, but all were asymptomatic and transient and did not require dose adjustment). 17202605
Sundar S, Jha TK, Thakur CP, Bhattacharya SK, Rai M. Oral miltefosine for the treatment of Indian visceral leishmaniasis. Trans R Soc Trop Med Hyg 2006; 100 Suppl 1: S26-33. (Review of the efficacy and safety of miltefosine in visceral leishmaniasis: “although 55% of patients had a slight asymptomatic rise in hepatic transaminase during the early treatment phase [week 1], values decreased to less than base-line values by week 2”). 16730038
Soto J, Toledo J, Valda L, Balderrama M, Rea I, Parra R, Ardiles J, et al. Treatment of Bolivian mucosal leishmaniasis with miltefosine. Clin Infect Dis 2007; 44: 350-6. (Among 72 patients with Bolivian mucosal leishmaniasis [L. braziliensis] treated with miltefosine [2.5 mg/kg/day] for 28 days, the 12 month cure rate was 83% for mild cases [limited to nose and nasal mucosa] and 58% for more extensive cases [palate, pharynx, larynx], while side effects included mild, asymptomatic AST elevations [peak value 39 U/L] with no change in mean values). 17205440
Bhattacharya SK, Sinha PK, Sundar S, Thakur CP, Jha TK, Pandey K, Das VR, et al. Phase 4 trial of miltefosine for the treatment of Indian visceral leishmaniasis. J Infect Dis 2007; 196: 591-8. (Open label trial of outpatient administration of oral miltefosine in 1132 adult and pediatric Indian patients with visceral leishmaniasis; the cure rate was 96% among the 971 who returned for follow up evaluation and adverse events included vomiting [8%], diarrhea [6%] and ALT elevations which were mild and occurred early, while mean ALT and AST values decreased with treatment). 17624846
Machado PR, Ampuero J, Guimarães LH, Villasboas L, Rocha AT, Schriefer A, Sousa RS, et al. Miltefosine in the treatment of cutaneous leishmaniasis caused by Leishmania braziliensis in Brazil: a randomized and controlled trial. PLoS Negl Trop Dis 2010; 4: e912. (Among 90 Brazilian patients [ages 2-65 years] with cutaneous leishmaniasis [L. braziliensis] treated with oral miltefosine vs intravenous pentavalent antimony, the cure rate was 75% vs 53% and side effects of miltefosine included vomiting [42%], nausea [40%], diarrhea [10%] and abdominal pain [23%]; no mention of ALT values or hepatoxicity). 21200420
Oliveira LF, Schubach AO, Martins MM, Passos SL, Oliveira RV, Marzochi MC, Andrade CA. Systematic review of the adverse effects of cutaneous leishmaniasis treatment in the New World. Acta Trop 2011; 118: 87-96. (Review of the adverse events associated with various therapies of cutaneous leishmaniasis including miltefosine; mentions the adverse effects of mild-to-moderate aminotransferase and creatinine elevations). 21420925
Chrusciak-Talhari A, Dietze R, Chrusciak Talhari C, da Silva RM, Gadelha Yamashita EP, de Oliveira Penna G, Lima Machado PR, et al. Randomized controlled clinical trial to access efficacy and safety of miltefosine in the treatment of cutaneous leishmaniasis caused by Leishmania (Viannia) guyanensis in Manaus, Brazil. Am J Trop Med Hyg 2011; 84: 255-60. (Among 90 patients [ages 4-59 years] with cutaneous leishmaniasis treated with oral miltefosine or parenteral antimony, the cure rate was 71% vs 54% and adverse events of miltefosine included vomiting [48%], nausea [9%], diarrhea [7%] and ALT elevations [10%] that were mild and resolved without dose modification).
Dorlo TP, Balasegaram M, Beijnen JH, de Vries PJ. Miltefosine: a review of its pharmacology and therapeutic efficacy in the treatment of leishmaniasis. J Antimicrob Chemother 2012; 67: 2576-97. (Review of the pharmacology and mechanism of action of miltefosine suggests that the steroid and fatty acid metabolism of the protozoan parasite is the major target of the anti-leishmaniasis activity). 22833634
Magerl M, Rother M, Bieber T, Biedermann T, Brasch J, Dominicus R, Hunzelmann N, et al. Randomized, double-blind, placebo-controlled study of safety and efficacy of miltefosine in antihistamine-resistant chronic spontaneous urticaria. J Eur Acad Dermatol Venereol 2013; 27: e363-9. (Among 73 patients with chronic idiopathic urticaria treated with miltefosine [50-150 mg daily] or placebo for 28 days, urticaria symptoms were less with miltefosine and side effects were generally mild with no serious adverse events and “no relevant changes” in laboratory test results). 22928719
Miltefosine (Impavido) for leishmaniasis. Med Lett Drugs Ther 2014; 56 (1451): 89-90. (Concise review of leishmaniasis and therapy with miltefosine including efficacy, safety and costs; mentions that elevations in aminotransferases and creatinine can occur with treatment). 25211304
Ostyn B, Hasker E, Dorlo TP, Rijal S, Sundar S, Dujardin JC, Boelaert M. Failure of miltefosine treatment for visceral leishmaniasis in children and men in South-East Asia. PLoS One 2014; 9): e100220. (Among 1016 Indian patients with visceral leishmaniasis treated with miltefosine for 28 days at 7 health centers, the cure rate was 94% at end of therapy and 86% 6 months later; comparisons of relapse [n=78] versus nonrelapse subjects [n=775] showed relapses were more frequent in men vs women [11% vs 6%] and children vs adults [12-16% vs 6%], but not with side effects vs without). 24941345
Vakil NH, Fujinami N, Shah PJ. Pharmacotherapy for leishmaniasis in the United States: focus on miltefosine. Pharmacotherapy 2015; 35: 536-45. (Review of the pharmacotherapy available for leishmaniasis in the US including pentavalent antimonials, pentamidine, amphotericin and miltefosine, the only oral therapy and one that has only recently become available, with common adverse effects being vomiting, diarrhea and transient liver enzyme level elevations). 25940658
Georgiadou SP, Makaritsis KP, Dalekos GN. Leishmaniasis revisited: Current aspects on epidemiology, diagnosis and treatment. J Transl Int Med 2015; 3: 43-50. (Review of the epidemiology, diagnosis and treatment of leishmaniasis). 27847886
van der Snoek EM, Couwenberg SM, Stijnis C, Kortbeek LM, Schadd EM. Two cases of cutaneous leishmaniasis in Dutch military personnel treated with oral miltefosine. J R Army Med Corps 2017; 163: 68-70. (Two Dutch citizens with cutaneous leishmaniasis acquired in Belize [L. braziliensis] and a Balearic island [L. donovani] were treated with miltefosine [50 mg three times daily for 28 days] and both had a beneficial response with mild creatinine elevations during therapy, but no changes in serum aminotransferase levels). 26661280

## OTHER REFERENCE LINKS

1. Recent References on Miltefosine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Miltefosine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Miltefosine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Miltefosine)